# Ashwagandha

## OVERVIEW

### Introduction

Ashwagandha is a popular Ayurvedic herb used as a general tonic, to improve health, increase energy and reduce stress and anxiety. Ashwagandha has not been implicated in causing serum enzyme elevations during therapy but recently has been implicated in cases of clinically apparent liver injury.

### Background

Ashwagandha is an Ayurvedic herb that is derived from extracts of the roots of Withania somnifera, a low growing evergreen shrub that is native to India and Southeast Asia. Ashwagandha is a Sanskrit word meaning horse smell. Sometimes called “Indian ginseng”, it is purported to have neuroprotective and antiinflammatory activities and is used to treat stress, anxiety, insomnia, fatigue, pain, skin diseases, diabetes, arthritis, and epilepsy. It is also used as a general tonic to increase energy, reduce fatigue and counteract the effects of aging. Its efficacy in these conditions has not been shown in controlled prospective studies, but it has been used in Ayurvedic medicine for centuries and is currently the most frequently used Ayurvedic medication. Ashwagandha has recently become a popular herbal product in Western countries. Withania somnifera extracts have more than 100 different chemical constituents including alkaloids, steroidal lactones, saponins, withanolides, withaferins and iron. The ingredient responsible for its purported activities and side effects is not known but withanolides are suspected. Extracts of ashwagandha root are often supplied as capsules or tablets in concentrations of 150 to 600 mg, which are taken one to three times daily, the total daily dose varying widely. Side effects are uncommon and have not been clearly defined. Large doses can cause gastrointestinal upset, diarrhea, nausea and vomiting, probably because of direct irritation to the intestinal mucosa.

### Hepatotoxicity

Despite widescale use, ashwagandha is considered generally safe and without major adverse effects. In clinical trials, there have been no reports of serum enzyme elevations occurring during therapy and no mention of serious adverse events or hepatotoxicity. Recently, however, cases of clinically apparent liver injury have been reported in patients taking commercial herbal products that are labelled as containing ashwagandha. Typically, the liver injury presented 2 to 12 weeks after starting ashwagandha usually with a cholestatic or mixed pattern of injury, jaundice, and pruritus. Immunoallergic and autoimmune features were not prominent. Occasional cases were hepatocellular initially, but in general the ensuing jaundice was protracted although it ultimately resolved completely. Rare instances of fatal liver injury or need for emergent liver transplantation have been reported particularly in patients with preexisting liver disease and cirrhosis. Because commercial herbal preparations are often mixtures of herbs and nutritional products and can be mislabeled and contain unknown herbs and medications, it is not always clear whether the reported cases were due to ashwagandha and one of its components or to a contaminant. In several reported cases, however, the commercial product being taken was tested and found to have ashwagandha without other contaminants. First reported in 2017, an increasing number of cases have been reported since. Thus, clinically apparent liver injury attributable to ashwagandha occurs although rarely, and its use should be avoided in patients with cirrhosis or advanced chronic liver disease.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatotoxicity from products containing ashwagandha is unclear. Among the many ingredients the withanolides have been most suspect. The possibility of mislabeling or adulteration with hepatotoxic herbal products is always an issue in commercial multiingredient dietary supplements.

### Outcome and Management

Most cases of ashwagandha associated liver injury have been mild-to-moderate in severity and self-limited in course, but fatal cases due to acute liver failure or acute-on-chronic liver failure have been described. Protracted jaundice in not uncommon, but chronic liver injury and vanishing bile duct syndrome have not been described. In most instances, the liver injury subsides within 1 to 4 months of discontinuing the herbal product. Rechallenge with the same product should be avoided.

Other names: Indian Ginseng, Winter Cherry, Poison Gooseberry

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ashwagandha – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/ashwagandha)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ashwagandha | 90147-43-6 | Unspecified | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 03 December 2024

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, Jin Bu huan, germander, chaparral leaf, skullcap and valerian, but not ashwagandha).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 735. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; ashwagandha is not discussed).
No authors listed. Ashwagandha. In, Natural Medicines: comprehensive database. http://naturaldatabase.therapeuticresearch.com (Compilation of short monographs on herbal medications and natural products).
Sudhir S, Budhiraja RD, Miglani GP, Arora B, Gupta LC, Garg KN. Pharmacological studies on leaves of Withania somnifera. Planta Med 1986; 52: 61-3. (In rat models of acute and chronic inflammation and carbon tetrachloride hepatotoxicity, alcohol extracts of Withania somnifera leaves decreased edema, inflammation and hepatic injury). 3703993
Mishra LC, Singh BB, Dagenais S. Scientific basis for the therapeutic use of Withania somnifera (ashwagandha): a review. Altern Med Rev 2000; 5: 334-46. (Review of published literature on Withania somnifera, a commonly used herb in Ayurvedic medicine, said to have antiinflammatory, antitumor, antistress, antioxidant, immune modulatory, hemopoietic and rejuvenating properties; toxicity studies have been done largely in laboratory animals, but adverse effects have not been demonstrated). 10956379
Chopra A, Lavin P, Patwardhan B, Chitre D. A 32-week randomized, placebo-controlled clinical evaluation of RA-11, an Ayurvedic drug, on osteoarthritis of the knees. J Clin Rheumatol 2004; 10: 236-45. (Controlled trial of a 32 week course of RA-11 versus placebo in 90 patients with osteoarthritis, found improvements in clinical symptoms, but no side effects or changes in serum ALT, AST or Alk P levels). 17043520
van der Hooft CS, Hoekstra A, Winter A, de Smet PA, Stricker BH. [Thyrotoxicosis following the use of ashwagandha]. Ned Tijdschr Geneeskd 2005; 149: 2637-8. Dutch. (32 year old previously healthy woman developed poor appetite, weight loss, shakiness, and palpitations 6 weeks after starting an herbal preparation of ashwagandha and shortly after increasing the dose [TSH <0.01 mU/L, free T4 33.9 pmol/L: normal 11-22], symptoms and abnormal thyroid tests resolving spontaneously soon after stopping). 16355578
Chopra A, Saluja M, Tillu G, Venugopalan A, Narsimulu G, Sarmukaddam S, Patwardhan B. Evaluating higher doses of Shunthi - Guduchi formulations for safety in treatment of osteoarthritis knees: A Government of India NMITLI arthritis project. J Ayurveda Integr Med 2012; 3: 38-44. (Among 92 patients with symptomatic osteoarthritis of the knees treated for 6 weeks with one of four herbal preparations [2 with ashwagandha], adverse events were uncommon and mild, and none of 45 patients developed serum ALT or AST elevations). 22529679
Kumar G, Srivastava A, Sharma SK, Rao TD, Gupta YK. Efficacy & safety evaluation of Ayurvedic treatment (Ashwagandha powder & Sidh Makardhwaj) in rheumatoid arthritis patients: a pilot prospective study. Indian J Med Res 2015; 141: 100-6. (Among 86 patients with rheumatoid arthritis treated with ashwagandha [5 gm twice daily] for 3 weeks followed by “Sidh Makardhwaj” for 4 weeks, symptom scores improved with treatment while ALT and AST levels did not change, serum mercury levels increased 4-fold). 25857501
Palliyaguru DL, Singh SV, Kensler TW. Withania somnifera: From prevention to treatment of cancer. Mol Nutr Food Res 2016; 60: 1342-53. (Review of the concept of chemoprevention of cancer and the evidence that ashwagandha might be effective based upon in vivo studies of apoptosis, angiogenesis, stress response, inflammation, and cancer prevention in animal models). 26718910
Choudhary D, Bhattacharyya S, Bose S. Efficacy and safety of ashwagandha (Withania somnifera (L.) Dunal) root extract in improving memory and cognitive functions. J Diet Suppl 2017; 14: 599-612. (Among 50 adults treated with ashwagandha [300 mg twice daily] or placebo for 8 weeks, measures of memory, attention and information processing improved more with ashwagandha, and tolerability was “excellent”; no mention of ALT elevations or hepatotoxicity). 28471731
Choudhary D, Bhattacharyya S, Joshi K. Body weight management in adults under chronic stress through treatment with Ashwagandha root extract: a double-blind, randomized, placebo-controlled trial. J Evid Based Complementary Altern Med 2017; 22: 96-106. (Among 52 adults with chronic stress treated with ashwagandha or placebo for 8 weeks, scores for perceived stress decreased more with the herbal extract and adverse events were uncommon and mild). 27055824
Inagaki K, Mori N, Honda Y, Takaki S, Tsuji K, Chayama K. A case of drug-induced liver injury with prolonged severe intrahepatic cholestasis induced by Ashwagandha. Kanzo 2017; 58: 448-54. Not in PubMed (20 year old man developed jaundice a month after increasing the dose of ashwagandha [bilirubin 20.7 mg/dL, ALT 94 U/L, Alk P 343 U/L, INR 1.02], jaundice persisting for more than 2 months, but ultimately resolving).
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss ashwagandha). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of ashwagandha). 29307848
Björnsson HK, Björnsson ES, Avula B, Khan IA, Jonasson JG, Ghabril M, Hayashi PH, Navarro V. Ashwagandha as a cause for liver injury. Liver Int. 2020;40:2035-2036. (Five cases of liver injury associated with ashwagandha use, 3 from Iceland and 2 from the U.S. in adults ages 21 to 62 years, presenting with symptoms and jaundice 2 to 12 weeks after starting the herbal supplement, enzyme pattern being mixed or cholestatic, frequently with prolonged jaundice but resolving in all within 1 to 5 months, with no fatalities and no evidence of chronic injury). 32475004
Ireland PJ, Hardy T, Burt AD, Donnelly MC. Drug-induced hepatocellular injury due to herbal supplement ashwagandha. J R Coll Physicians Edinb. 2021;51:363-365. (39 year old woman developed nausea and vomiting 6 weeks after starting ashwagandha [154 mg] on alternative days for anxiety [bilirubin 9.0 rising to 19.1 mg/dL, ALT 1514 U/L, Alk P 184 U/L, prothrombin time 14 sec], with slow recovery on ursodiol therapy). 34882134
Weber S, Gerbes AL. Ashwagandha-induced liver injury: self-reports on commercial websites as useful adjunct tools for causality assessment. Am J Gastroenterol. 2021;116:2151-2152. (40 year old man developed jaundice and pruritus 20 days after switching to a new brand of ashwagandha [Now Ashwagandha 450 mg], with bilirubin rising from ~ 8.5 to 25.2 but with only modest elevations in serum ALT and AST; few details provided). 34187981
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; Ashwagandha is listed as having 9 cases [~1%] in the literature). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], none were attributed to ashwagandha). 33434654
Pusec CM, Wolsky R, Llerena C, Sura P. A case of supplement-induced hepatitis. Cureus. 2022;14:e30433. (43 year old woman developed abdominal pain and fatigue followed by jaundice after taking ashwagandha in high doses [2100 mg daily] for a year and while also on ibuprofen [1200 mg daily] and modest alcohol intake, liver biopsy showing marked macro- and micro-steatosis [bilirubin 13.5 mg/dL, ALT 70 U/L, Alk P 422 U/L], improving after stopping the herbal supplement). 36407193
Patel AD, Pinsker BL, Wall A, Arbogast M, King LY, Sherzoy S. Itching to find a diagnosis. Clin Liver Dis (Hoboken). 2022;20:77-80. (65 year old man developed abdominal pain and weight loss followed by jaundice while taking a dietary supplement with ashwagandha for an unknown duration in an unknown dose [bilirubin 2.0 rising to 21 mg/dL, ALT 126 U/L, Alk P 96 U/L], resolving over the following 2-3 months). 36187371
Siddiqui S, Ahmed N, Goswami M, Chakrabarty A, Chowdhury G. DNA damage by Withanone as a potential cause of liver toxicity observed for herbal products of Withania somnifera (Ashwagandha). Curr Res Toxicol. 2021;2:72-81. (The ashwagandha metabolite withanone [“win”] can form non-labile adducts with nucleosides and DNA which may interfere with DNA transcription, replication, and repair and might be detoxified by glutathione in a manner similar to acetaminophen). 34345852
Casiano-Manzano S, Torres-Larrubia M, Masa-Caballero A, Jiménez-Colmenarez Z, Martín-Noguerol E, Fernández-Bermejo M, Solís-Muñoz P. Changing perspectives: unveiling the risks of ashwagandha-induced hepatotoxicity. Rev Esp Enferm Dig. 2023 Nov 20. Epub ahead of print. (Short report of a 33 year old Spanish man who developed jaundice and pruritus two months after starting ashwagandha for anxiety [bilirubin 10.7 rising to 21.1, ALT and Alk P levels not provided], with resolution after stopping). 37982556
Philips CA, Valsan A, Theruvath AH, Ravindran R, Oommen TT, Rajesh S, Bishnu S, et al.; Liver Research Club India. Ashwagandha-induced liver injury—A case series from India and literature review. Hepatol Commun. 2023;7:e0270. (8 cases of ashwagandha related liver injury from 3 hospitals in India from 2019 through 2022, included 6 men and 2 women, ages 31 to 75, 7 taking the herb for 2-12 weeks and one for more than a year, for stress or sleep, presenting with median bilirubin 13.8 mg/dL, ALT 173 U/L, Alk P 204 U/L, 5 having preexisting chronic liver disease, 3 having acute-on-chronic liver failure and dying, the remaining resolving although often after prolonged cholestasis). 37756041
Bokan G, Glamočanin T, Mavija Z, Vidović B, Stojanović A, Björnsson ES, Vučić V. Herb-induced liver injury by Ayurvedic ashwagandha as assessed for causality by the updated RUCAM: an emerging cause. Pharmaceuticals (Basel). 2023;16:1129. (Two case reports; 36 year old man developed jaundice 6 months after starting ashwagandha [450 mg 3 times daily] for fertility [bilirubin 2.6 mg/dL, ALT 1396 U/L, Alk P 432 U/L, INR 0.98] and a 30 year old woman developing rash 3 weeks and jaundice 6 weeks after starting ashwagandha [450 mg once daily] for fertility [bilirubin 12.6 mg/dL, ALT 111 U/L, Alk P 147 U/L, INR 0.93], both cases resolving within 2 months of stopping). 37631044
Tóth M, Benedek AE, Longerich T, Seitz HK. Ashwagandha-induced acute liver injury: a case report. Clin Case Rep. 2023;11:e7078. (65 year old man living in Germany developed jaundice within 4 weeks of starting ashwagandha for “troubled thoughts” [bilirubin 17.3 mg/dL, ALT 54 U/L, Alk P 298 U/L], resolving within 5 months of stopping). 36937644
Lubarska M, Hałasiński P, Hryhorowicz S, Mahadea DS, Łykowska-Szuber L, Eder P, Dobrowolska A, et al. Liver dangers of herbal products: a case report of ashwagandha-induced liver injury. Int J Environ Res Public Health. 2023;20:3921. (23 year old Polish man developed fatigue and jaundice approximately 3 months after starting ashwagandha [bilirubin 11.5 rising to 28.1 mg/dL, ALT 490 U/L, Alk P 227 U/L, INR 1.24], resolving within 3.5 months of stopping). 36900932
Suryawanshi G, Abdallah M, Thomson M, Desai N, Chauhan A, Lim N. Ashwagandha-associated acute liver failure requiring liver transplantation. Am J Ther. 2023;30:e80-e83. (41 year old woman developed fatigue 2 months after starting ashwagandha and progesterone and stopped therapy but continued to have symptoms and then jaundice one month later [bilirubin 10.4 rising to 24.6 mg/dL, ALT 3400 U/L, Alk P 102 U/L] and 10 days later with progressive hepatic failure [encephalopathy and INR 6.2], undergoing successful emergency liver transplantation). 36321995
Vazirani S, Kothari A, Fujimoto J, Gomez M. Supplements are not a synonym for safe: suspected liver injury from ashwagandha. Fed Pract. 2023;40:315-319. (48 year old man with severe alcohol use disorder started taking “TestBoost” [containing 8 ingredients including ashwagandha, long jack, eleuthero, ginseng, mushroom extract, bindi and horny goat weed] for alcohol withdrawal symptoms and developed jaundice 3 days later [bilirubin 13.6 mg/dL, ALT 49 U/L, AST 58 U/L Alk P 98 U/L, INR 1.1], with slow recovery and relapse in alcohol use in follow up). 38562158
Almuzghi F, Abdelmalik A, Abuhlaiga M. Ashwagandha-induced hepatic injury: a case report. Cureus. 2024;16:e71576. (22 year old Libyan female developed itching and fatigue after 2 days followed by jaundice after 7 days of starting ashwagandha for anxiety [bilirubin 2.6 rising to 12.8 mg/dL, ALT 186 to 315 U/L, Alk P 119 to 150 U/L, INR 1.0], resolving 2 months after stopping). 39553154
Likhitsup A, Chen VL, Fontana RJ. Estimated exposure to 6 potentially hepatotoxic botanicals in US adults. JAMA Netw Open. 2024;7:e2425822. (Analysis of a database of the U.S. adult population during 2023 and 2024 found that ashwagandha was one of the most frequently used herbal supplements). 39102266
Philips CA, Theruvath AH. A comprehensive review on the hepatotoxicity of herbs used in the Indian (Ayush) systems of alternative medicine. Medicine (Baltimore). 2024;103:e37903. (Review of the literature on liver injury attributed to Ayurvedic medicines, mentions 23 cases of clinically apparent liver injury due to ashwagandha have been reported, with typical onset of cholestatic hepatitis after a month of use, most cases resolving spontaneously, but occasional instances of fatal liver failure or chronic injury). 38640296
Vaidya VG, Gothwad A, Ganu G, Girme A, Modi SJ, Hingorani L. Clinical safety and tolerability evaluation of Withania somnifera (L.) Dunal (Ashwagandha) root extract in healthy human volunteers. J Ayurveda Integr Med. 2024;15:100859. (Among 18 healthy adult men treated with ashwagandha 500 mg twice daily for 1 month, therapy was well tolerated and there were no changes in body weight, blood counts, serum ALT or AST, with minor elevation in Alk P [140 to 164 U/L] and decrease in total bilirubin levels [0.84 to 0.65 mg/dL]). 38154316

## OTHER REFERENCE LINKS

1. Recent References on Ashwagandha: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ashwagandha+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ashwagandha: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ashwagandha)